# Atenolol

## OVERVIEW

### Introduction

Atenolol is a cardioselective beta-blocker that is widely used in the treatment of hypertension and angina pectoris. Atenolol has been linked to rare cases of drug induced liver injury, some of which have been fatal.

### Background

Atenolol (a ten' oh lol) is considered a “selective” beta-adrenergic receptor blocker in that it has potent activity against beta-1 adrenergic receptors which are found in cardiac muscle, but has little or no activity against beta-2 adrenergic receptors found on bronchial and vascular smooth muscle. Atenolol was approved for use in the United States in 1981 and is still widely used in the therapy of hypertension and angina pectoris. Atenolol is also used to reduce the risk of cardiovascular mortality in patients with coronary artery disease. Atenolol is available in 25, 50 and 100 mg tablets in generic forms as well as under the trade name of Tenormin. It is also available in fixed combinations with a diuretic such as chlorthalidone (Tenoretic and others). Parenteral formulations for intravenous use are also available. The usual oral dose of atenolol in adults is 25 to 50 mg once daily initially, with subsequent adjustment based upon clinical response and tolerance, but rarely beyond 100 mg daily. Common side effects include bradycardia, hypotension, fatigue, dizziness, depression, memory loss and impotence. At high doses, atenolol is less cardioselective and can cause bronchospasm. As with all beta-blockers, sudden withdrawal can trigger rebound hypertension.

### Hepatotoxicity

Atenolol therapy has been associated with mild-to-moderate elevations of serum aminotransferase levels in 1% to 2% of patients. These elevations, however, are usually asymptomatic and transient and resolve even with continuation of therapy. A few instances of clinically apparent, acute liver injury attributable to atenolol have been reported. In view of its wide scale use, atenolol induced liver injury is exceedingly rare. The onset of injury has been within 1 to 4 weeks and pattern of liver enzyme elevations has been hepatocellular or mixed. Symptoms of hypersensitivity (rash, fever, eosinophilia) are uncommon as is autoantibody formation. Most cases are self-limiting and resolve rapidly once atenolol is stopped; however, at least one fatal instance has been reported.

Likelihood score: D (Possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of drug induced liver injury from atenolol is not known. The agent has little hepatic metabolism and is excreted largely unchanged in the urine. The few cases of acute liver injury attributed to atenolol were likely idiosyncratic.

### Outcome and Management

The severity of liver injury due to atenolol ranges from mild serum aminotransferase elevations to acute hepatitis with jaundice. In large case series of acute liver failure due to medications, atenolol has been listed as a rare cause. Rechallenge has not been reported, but should be avoided. There is little information about cross reactivity among the beta-blockers to hepatic injury. Switching to another beta-blocker after atenolol related acute liver injury should be done with caution and prospective monitoring.

References to the safety and potential hepatotoxicity of atenolol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## CASE REPORT

### Case 1. Acute liver injury and jaundice from atenolol.

[Modified from a case in the database of the Drug-Induced Liver Injury Network]

A 44 year old man with hypertension was treated with atenolol and 4 weeks later developed nausea, vomiting, light colored stools and weight loss. He was subsequently hospitalized when found to be jaundiced. He admitted to drinking two or three beers per day, but had no history of alcohol problems, liver disease or risk factors for viral hepatitis. Other medications were limited to various vitamins and herbal preparations including coenzyme Q10, omega-3 fatty acids, a vitamin B complex and glucosamine/condroitin which he had taken for several years. On presentation, he had a low grade fever and jaundice, but no rash or peripheral manifestations of chronic liver disease. Serum aminotransferase and alkaline phosphatase levels were both elevated and total serum bilirubin was 5.4 mg/dL (Table). He tested negative for hepatitis A, B, C and E virus infection and autoantibody reactivity. An abdominal ultrasound was unremarkable. A liver biopsy showed multiple epithelioid granulomas and acute hepatic injury with prominence of eosinophils in portal areas, suggestive of a drug reaction. Atenolol was discontinued and he began to improve within a week. When seen in follow up one and 3 months after initial presentation, all liver tests were normal.

#### Key Points

Medication: | Atenolol (25 mg daily)
Pattern: | Hepatocellular (R=7.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks to onset of symptoms and jaundice
Recovery: | 4 weeks
Other medications: | Vitamins, glucosamine, chondroitin, omega-3-fatty acids

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Atenolol stopped after 5 weeks of therapy (25 mg daily)
5 | 0 | 497 | 231 | 5.4 | Eosinophils 9%
5.2 | 0.3 | 486 | 189 | 5.6 | Liver biopsy
5.4 | 0.4 | 555 | 216 | 3.1
7 | 21 | 41 | 97 | 1.2
9 | 4 | 25 | 71 | 0.6
12 | 7 | 32 | 57 | 1.0
18 | 13 | 19 | 61 | 0.5
Normal Values | | <41 | <140 | <1.2

#### Comment

The acute liver injury was typical of what has been described in cases of beta-blocker induced liver injury with a latency of 4 weeks and a mild, self-limited hepatitis and a hepatocellular pattern of serum enzyme elevations. Recovery was prompt once atenolol was stopped. Liver histology also supported the diagnosis. The patient was also taking a variety of over-the-counter vitamins, nutritional supplements and herbal products, but had taken the same formulations for several years and restarted them without incident after recovery from the acute liver injury. This patient had not taken other beta-blockers and had no history of allergy or previous drug induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atenolol – Generic, Tenormin®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=atenolol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Atenolol | 29122-68-7 | C14-H22-N2-O3 | Atenolol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Atenolol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Atenolol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Atenolol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Atenolol)